# Propofol

## OVERVIEW

### Introduction

Propofol is the mostly commonly used parenteral anesthetic agent in the United States, extensively used for minor and outpatient surgical procedures because of its rapid onset and reversal of action, and in intensive care units (ICUs) for maintenance of coma. Propofol has been associated with rare instances of idiosyncratic acute liver injury; in addition, prolonged high dose propofol therapy can cause the “Propofol infusion syndrome” which is marked by bradyarrhythmias, metabolic acidosis, rhabdomyolysis, hyperlipidemia and an enlarged or fatty liver.

### Background

Propofol (proe' poe fol) is an intravenously administered anesthetic agent that is widely used for minor and outpatient surgical procedures. Chemically, propofol is 2,6-diisopropylphenol and its mechanism of action is similar to the barbiturates and benzodiazepines, binding to gamma amino butyric acid (GABA) receptors in the central nervous system. The binding is to a different site than the benzodiazepines and causes marked increases the neuroinhibitory actions of the GABA receptor resulting in increased chloride conduction and hyperpolarization of neurons. Propofol also lowers intracerebral pressure and reduces cerebral oxygen consumption. Importantly, propofol has the unique pharmacokinetic and pharmacodynamic features of rapid onset of action and rapid reversal with stopping which makes it a valuable agent for induction of anesthesia and for short-term procedures. Propofol was approved for use in the United States in 1989 and it has become widely used for induction of general anesthesia, as an sole anesthetic agent for short, minor surgical and endoscopic procedures, and as a means of prolonged sedation in critically ill patients in intensive care units. Propofol is highly insoluble in water and is given in a lipid emulsion usually in a 1% solution of 10% soy bean oil. The typical induction dose of propofol is 1.5 to 2.5 mg/kg followed with small boluses or a constant low dose infusion for maintenance of anesthesia. Propofol is available generically and under the brand name Diprivan. Propofol should be administered by a trained anesthesiologist or anesthetist with adequate availability of ventilatory and cardiac support. Deaths from propofol overdose have been reported, particularly with its abuse.

### Hepatotoxicity

Liver test abnormalities are not common among patients during or after propofol anesthesia when given for a few hours. Indeed, propofol can be used safely in patients with cirrhosis and may be the preferred anesthetic agent in patients with minimal hepatic encephalopathy. However, isolated case reports of hepatitis arising within days or weeks after propofol anesthesia for minor procedures have been published. The pattern of serum enzyme elevations was usually hepatocellular and some instances were accompanied by jaundice and prolongation of prothrombin time activity (Case 1). Immunoallergic features and autoantibodies during the liver injury were absent. In most published instances, other diagnoses such as ischemic hepatitis and hepatitis C were not completely excluded.

Prolonged infusions of propofol can result in a distinctive clinical syndrome known as the propofol infusion syndrome. It is marked by combinations of cardiac bradyarrhythmias, metabolic acidosis, rhabdomyolysis, hyperlipidemia, renal insufficiency and death from cardiovascular collapse. The syndrome generally arises after 2 to 3 days of sedation in association with use of higher doses of propofol (>5 mg/kg/hour) and may be more common in children than adults. Early termination of the propofol infusion can result in reversal of the syndrome, but the mortality rate in published series has been greater than 50%. On autopsy, patients with the propofol infusion syndrome may have hepatic microvesicular steatosis, explaining the lactic acidosis that frequently accompanies the muscle and heart abnormalities. However, jaundice and marked elevations in typical liver associated enzymes in this syndrome are uncommon. In some instances, both the urine and the liver have been described as being green in color, returning to normal soon after propofol is stopped. A mild form of this syndrome may occur earlier during infusions, as shown by lactic acidosis arising within 2 to 24 hours of starting propofol which is rapidly reversed upon stopping. More than 50 instances of propofol infusion syndrome have been described in the literature with a high mortality rate, although most deaths were due to cardiac involvement. Some instances of propofol infusion syndrome and lactic acidosis have been associated with higher than expected plasma levels of propofol, perhaps due to idiosyncratic differences in pharmacokinetics or miscalculation of administered dose.

Likelihood score: A[H] (well established cause of fatty liver injury when given in high doses over several days as a part of the propofol infusion syndrome) and D (possible rare cause of idiosyncratic, clinically apparent liver injury when given short term in conventional doses).

### Mechanism of Injury

The mechanism by which propofol causes liver injury is not known. The idiosyncratic cases are likely due to a metabolic byproduct as propofol is extensive metabolized in the liver by multiple P450 isoforms. The propofol infusion syndrome is likely due to direct mitochondrial injury which primarily affects myocardial and skeletal muscle, but which also can cause mitochondrial injury in hepatocytes resulting in microvesicular fat in the liver. The cardiac manifestations tend to be most prominent and are the usual reason for fatalities. There may be a genetic predisposition (perhaps a subclinical form of a mitochondrial disorder) to the propofol infusion syndrome or lactic acidosis.

### Outcome and Management

Management of the propofol infusion syndrome requires prompt discontinuation of the medication and cardiorespiratory support. Hemodialysis or hemofiltration may also be warranted. Lactic acidosis should be managed with intravenous fluids, 20% glucose infusions and bicarbonate. The idiosyncratic acute liver injury due to propofol is usually self-limited. Several reports of recurrence of propofol infusion syndrome upon restarting the anesthetic have been reported and reexposure should be avoided.

Drug Class: Anesthetic Agents

## CASE REPORT

### Case 1. Acute hepatitis after propofol anesthesia.(1)

A 62 year old woman underwent colonoscopy under propofol anesthesia and developed nausea, vomiting and epigastric pain 2 weeks later. She had no history of liver disease, took no medications, did not drink alcohol excessively and had no risk factors for viral hepatitis. She was jaundiced but was without signs of chronic liver disease. Laboratory testing showed marked elevations in ALT and AST with moderate increase in alkaline phosphatase (Table). She was admitted for evaluation. Tests for hepatitis A and B, EBV and cytomegalovirus were negative and autoantibodies were not found. She had antibody to hepatitis C (anti-HCV), although routine laboratory tests taken 6 months earlier had showed normal ALT levels. An abdominal CT scan showed no evidence of biliary obstruction. A liver biopsy showed an acute hepatocellular injury with mild fibrosis with changes suggesting a drug induced injury, rather than chronic hepatitis C. Subsequently, her symptoms resolved and laboratory tests had were falling when she was seen three weeks after onset.

#### Key Points

Medication: | Propofol anesthesia (250 mg, total dose)
Pattern: | Hepatocellular (R=10.2)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 14 days
Recovery: | Unclear, probably within 6 weeks
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | Pre | 11 | 94 | 0.2
Outpatient colonoscopy under propofol anesthesia
14 days | 0 | 1313 | 322 | 4.8 | Admitted. INR=0.96
16 days | 2 days | 2219 | 311 | 6.7
17 days | 3 days | 2008 | 289 | 7.2
23 days | 8 days | 1504 | 225 | 10.0 | INR=1.34
25 days | 10 days | 914 | 232 | 10.5
4 weeks | 2 weeks | 197 | 196 | 7.1
5 weeks | 3 weeks | 62 | 162 | 4.4
Normal Values | | <50 | <125 | <1.2

#### Comment

A possible case of drug induced liver injury in which the only medication exposure was propofol anesthesia given 2 weeks before clinical presentation with symptoms and jaundice. The course was somewhat prolonged and the INR rose slightly suggesting that the injury was significant. Propofol anesthesia has been used in several million patients and drug induced liver injury as a result must be very rare. An alternative explanation in this case was acute hepatitis C, which was perhaps the more likely diagnosis, but HCV RNA results and follow up testing results were not provided.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Propofol – Generic, Diprivan®

DRUG CLASS

Anesthetics

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Propofol)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Propofol | 2078-54-8 | C12-H18-O

## CITED REFERENCE

1 Nguyen HD, Borum ML. (2009). Acute hepatitis in a patient given propofol during colonoscopy. South Med J.

## ANNOTATED BIBLIOGRAPHY

References updated: 10 July 2020

Patel PM, Pearn ML, Patel HH, Roth DM. Propofol. General anesthetics and therapeutic gases. In, Brunton LL, Hilal-Dandan, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 387-404. (Textbook of pharmacology and therapeutics).
Kawar P, Briggs LP, Bahar M, McIlroy PDA, Dundee JW, Merrett JD, Nesbitt GS. (1982). Liver enzyme studies with disoprofol (ICI 35,868) and midazolam. Anaesthesia. (Controlled trial of propofol vs midazolam vs thiopentone as induction agent for nitrous oxide anesthesia in 72 patients with monitoring of serum enzymes over next 2 weeks [3 determinations]; average levels did not rise and minor elevations occurred equally in all three groups).
Stark RD, Binks SM, Dutka VN, O'Connor KM, Arnstein MJ, Glen JB. (1985). A review of the safety and tolerance of propofol ('Diprivan'). Postgrad Med J. (None of 155 patients given propofol anesthesia who were closely monitored in follow up had ALT elevations above 2 times ULN; no mention of hepatotoxicity or jaundice).
[Adverse effects of propofol (Diprivan)]. Ugeskr Laeger 1990; 152: 1176. Danish. (The original report of what was later called the propofol infusion syndrome).
Parke TJ, Stevens JE, Rice ASC, Greenway CL, Bray RJ, Smith PJ, Waldmann CS, et al. (1992). Metabolic acidosis and fatal myocardial failure after propofol infusion in children: five case reports. BMJ. (Initial report of propofol infusion syndrome in English: 5 children, ages 0.1 to 6 years on propofol at doses >4 mg/kg/hour for 4-6 days developed fatal arrhythmias and metabolic acidosis; microvesicular fat in liver on autopsy in 2).
Motsch J, Schmidt H, Bach A, Böttiger BW, Böhrer H. (1994). Long-term sedation with propofol and green discolouration of the liver. Eur J Anaesthesiol. (56 year old man with complications of bowel resection for cancer requiring repeated open peritoneal lavage and ventilatory support, was treated with propofol and found to have "lawn-like" green color to liver 7 days later [bilirubin 5.9 mg/dL, ALT 20 U/L, Alk P 346 U/L, thought to be due to sepsis]; 2 weeks after propofol was stopped the liver was normal color).
Müller C, Jelinek T, Endres S, Loeschke K. (1996). Z Gastroenterol. (27 year old woman with Alagille syndrome developed severe cholestasis [bilirubin 59 mg/dL, ALT 61 U/L, Alk P 269 U/L] and ascites 4 weeks after general anesthesia with propofol and isoflurane; eventually resolved).
Marinella MA. (1996). Lactic acidosis associated with propofol. Chest. (30 year old woman intubated for asthma and given iv propofol developed lactic acidosis within 2 hours which improved on stopping).
Cray SH, Robinson BH, Cox PN. (1998). Lactic acidemia and bradyarrhythmia in a child sedated with propofol. Crit Care Med. (10 month old given propofol at 10 mg/kg/hour for 4 days developed green urine, lactic acidosis and fatal bradyarrhythmia; microvesicular steatosis in the liver on autopsy).
Hanna JP, Ramundo ML. (1998). Rhabdomyolysis and hypoxia associated with prolonged propofol infusion in children. Neurology. (Two children, ages 7 and 17 years, developed fatal arrhythmias, lactic acidosis, rhabdomyolysis after 1-3 days of propofol sedation for status epilepticus).
Bray RJ. (1998). Propofol infusion syndrome in children. Paediatr Anaesth. (Summary of 18 cases of propofol infusion syndrome in children, only 3 of whom survived; usually received >4 mg/kg/hour for 1-5 days, dying of bradyarrhythmias, often with acidosis and hyperlipidemia and enlarged or fatty liver; among 9 children treated in one unit with propofol for at least 48 hours, 3 developed fatal syndrome compared to 0 of 26 sedated with other agents).
Hatch DJ. (1999). Propofol-infusion syndrome in children. Lancet. (Commentary on article by Bray in 1998 calling for a clinical trial to reassess safety of iv propofol in children).
Bray RJ. (1999). Propofol-infusion syndrome in children. Lancet. (Response to letter from Hatch in 1999 citing ethical concerns of doing clinical trials of propofol in children).
Murdoch SD, Cohen AT. (1999). Propofol-infusion syndrome in children. Lancet. (Survey of 218 ICUs in UK; 47 reported that they used propofol in children including 11 of 18 pediatric units, limiting to doses of 1-4 mg/kg/hour and only for short term).
Mehta N, De Hunter C, Parviz H, Nadel S, Britto J. (1999). Short-term propofol infusions in children. Lancet. (18 month old developed acidosis 5 hours after starting propofol with subsequent arrhythmia and renal and respiratory failure).
Stelow EB, Johari VP, Smith SA, Crosson JT, Apple FS. (2000). Propofol-associated rhabdomyolysis with cardiac involvement in adults: chemical and anatomic findings. Clin Chem. (47 year old woman and 41 year old man developed rhabdomyolysis with marked CPK and troponin I elevations within 2-4 hours of starting high doses of iv propofol during intubation for asthma; one died).
Perrier ND, Baerga-Varela Y, Murray MJ. (2000). Death related to propofol use in an adult patients. Crit Care Med. (18 year old man with head trauma given iv propofol [5.8-7.6 mg/kg/hour] developed arrhythmias on day 5 followed by progressive lactic acidosis, hyperlipidemia, and death in asystole).
Cannon ML, Glazier SS, Bauman LA. (2001). Metabolic acidosis, rhabdomyolysis, and cardiovascular collapse after prolonged propofol infusion. J Neurosurg. (13 year old girl given propofol [6 mg/kg/hour] in ICU for 4 days developed green urine, acidosis and right bundle branch block with coved ST segments and subsequent cardiovascular collapse; autopsy showed "no hepatic steatosis").
Kelly DF. (2001). Propofol-infusion syndrome. J Neurosurg. (Editorial on case described by Cannon et al., reporting a case in an adult man with acidosis and cardiovascular collapse after 55 hours of propofol sedation).
Cremer OL, Moons KG, Bouman EA, Kruijswijk JE, de Smet AM, Kalkman CJ. (2001). Long-term propofol infusion and cardiac failure in adult head-injured patients. Lancet. (Retrospective review of 67 head injured ICU patients who received propofol for more than 24 hours; 7 developed propofol infusion syndrome, onset in 24-48 hours with arrhythmias and 6 with acidosis, usually with higher doses [>5 mg/kg/hour]).
Anand K, Ramsay MA, Crippin JS. (2001). Hepatocellular injury following the administration of propofol. Anesthesiology. (17 year old girl developed nausea the day after propofol anesthesia for outpatient hernia repair, ALT rising to 1567 U/L [day 3] but normal Alk P and bilirubin, resolving within 2 weeks).
Badr AE, Mychaskiw G, Eichhorn JH. (2001). Metabolic acidosis associated with a new formulation of propofol. Anesthesiology. (21 year old woman with intracerebral bleed treated with iv propofol [4.5-9 mg/kg/hour] developed lactic acidosis after 2 days and died after 3).
Wolf A, Weir P, Segar P, Stone J, Shield J. (2001). Impaired fatty acid oxidation in propofol infusion syndrome. Lancet. (2 year old boy with head trauma given propofol [5.2 mg/kg/hour] developed renal insufficiency on day 4 followed by arrhythmias and lactic acidosis, responded to stopping propofol and hemofiltration; high C5-acylcarnitide suggested impaired mitochondrial fatty acid oxidation).
Kang TM. (2002). Propofol infusion syndrome in critically ill patients. Ann Pharmacother. (Review of propofol infusion syndrome; mentions unpublished prospective, randomized clinical trial in children which found higher rate of death [8% and 11%] with propofol than standard agents [4%]).
Ernest D, French C. (2003). Propofol infusion syndrome-report of an adult fatality. Anaesth Intensive Care. (31 year old man with head injury maintained on propofol anesthesia [average 5.8 mg/kg/hour] developed EKG changes and CPK rise [11,100 U/L] starting on day 4, and dying with lactic acidosis and asystole on day 7).
Holzki J, Aring C, Gillor A. (2004). Death after re-exposure to propofol in a 3-year-old child: a case report. Paediatr Anaesth. (3 year old girl ventilated for aspiration pneumonia with propofol developed acidosis after 15 hours [20 mg/kg/hour], improving on stopping propofol, but acutely worsening within 8 hours of restarting with arrhythmias and cardiovascular collapse).
Koch M, De Backer D, Vincent JL. (2004). Lactic acidosis: an early marker of propofol infusion syndrome?. Intensive Care Med. (5 year old girl with embolization of an arterial-venous malformation was sedated with propofol [15 mg/kg/hour] developed lactic acidosis within 6 hours, reversing upon stopping).
Burow BK, Johnson ME, Packer DL. (2004). Metabolic acidosis associated with propofol in the absence of other causative factors. Anesthesiology. (31 year old woman developed acidosis between 5-6.5 hours of propofol anesthesia [~5 mg/kg/hour], reversing rapidly with discontinuation).
Salengros JC, Velghe-Lenelle CE, Bollens R, Engleman E, Barvals L. (2004). Lactic acidosis during propofol-remifentanil anaesthesia in an adult. Anesthesiology. (64 year old man developed tachycardia after 3 hours of propofol anesthesia [~8 mg/kg/hour] with subsequent lactic acidosis [lactate rising from 1.45 to 8.57 mM, pH falling from 7.43 to 7.28], but rapid resolution on stopping propofol after 4.5 hours).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl. (Among ~50,000 liver transplants done in the United States between 1990 and 2002, 137 [0.2%] were done for idiosyncratic drug induced acute liver failure, but none were attributed to propofol).
Liolios A, Guét JM, Scholtes JL, Raftopoulos C, Hantson P. (2005). Propofol infusion syndrome associated with short-term large-dose infusion during surgical anesthesia in an adult. Anesth Analg. (42 year old man developed lactic acidosis within 15 hours of starting propofol [2.3-9 mg/kg/hour], rapidly reversing with stopping).
Haase R, Sauer H, Eichler G. (2005). Lactic acidosis following short-term propofol infusion may be an early warning of propofol infusion syndrome. J Neurosurg Anesthesiol. (7 year old boy developed increased lactate levels 5 hours after receiving 40 minutes of propofol sedation spontaneously improving).
Farag E, DeBoer G, Cohen BH, Niezgoda J. (2005). Anesthesiology. (Letter suggesting that patients developing lactic acidosis on propofol have a subclinical mitochondrial disorder, mentioning that use of propofol in patients undergoing muscle biopsy for mitochondrial diseases was complicated by prolonged recovery).
Chukwuemeka A, Ko R, Ralph-Edwards A. (2006). Short-term low-dose propofol anaesthesia associated with severe metabolic acidosis. Anaesth Intensive Care. (45 year old man undergoing coronary bypass graft developed lactic acidosis after 6 hours of propofol anesthesia, reversing rapidly on stopping).
Polo-Romero FJ. (2006). Propofol is not so safe for ERCP. Hepatobiliary Pancreat Dis Int. (65 year old man received propofol during ERCP for biliary pancreatitis and 48 hours later had rise in ALT [50 times ULN], Alk P [slight increase] and bilirubin [8.9 mg/dL], with rapid recovery and normal values 2 weeks later; suspected propofol as cause of acute liver injury).
Kam PCA, Cardone D. (2007). Propofol infusion syndrome. Anaesthesia. (Systematic review including history and definition of propofol infusion syndrome; listing of 61 cases, including 38 deaths and 32 pediatric cases; discussion of mechanisms of injury and management).
Fodale V, La Monaca E. (2008). Propofol infusion syndrome: an overview of a perplexing disease. Drug Saf. (Review of propofol infusion syndrome including summary and listing of all published cases).
Vanlersberghe C, Camu F. (2008). Propofol. Handb Exp Pharmacol. (Extensive review of pharmacology, metabolism, mechanism of action and pharmacologic effects of propofol).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, propofol was implicated as possibly the cause in one case that was later attributed to cefazolin).
Laquay N, Pouard P, Silicani MA, Vaccaroni L, Orliaguet G. (2008). Early stages of propofol infusion syndrome in paediatric cardiac surgery: two cases in adolescent girls. Br J Anaesth. (12 and 16 year old girls had second cardiac operations under propofol anesthesia [<3 mg/kg/hour] and developed rising lactate levels within 2-6 hours, reversing after stopping).
Tan CK, Lai CC, Cheng KC. (2008). Propofol-related green urine. Kidney Int. (52 year old man with cirrhosis was given single bolus of iv propofol [100 mg] and developed green urine one hour later).
Polo-Romero FJ, Paricio P, Tovar A, Alonso JM. (2008). Propofol-induced acute toxic hepatitis after brief sedation for endoscopic retrograde cholangiopancreatography. Endoscopy. (Same case as described by Polo-Romero in 2006).
Rison RA, Ko DY. (2009). Isolated fatty liver from prolonged propofol use in a pediatric patient with refractory status epilepticus. Clin Neurol Neurosurg. (13 year old girl with status epilepticus and complex medical course with multiple medications developed hepatomegaly and "macrofasicular fatty deposits" on liver biopsy after 56 days of propofol sedation [2 mg/kg/hour] with preexisting ALT elevation rising from 135 to 380 U/L; high ammonia levels but no mention of Alk P or bilirubin).
Orsini J, Nadkarni A, Chen J, Cohen N. (2009). Propofol infusion syndrome: case report and literature review. Am J Health Syst Pharm. (36 year old woman with HCV/HIV coinfection developed rash, ALT [536 U/L] and CPK [36,327 U/L] elevations with normal lactate levels and no acidosis after 7 days of iv propofol [1.5 mg/kg/hour], resolving on switching to phenobarbital; patient had received multiple other medications).
Nguyen HD, Borum ML. (2009). Acute hepatitis in a patient given propofol during colonoscopy. South Med J. (62 year old woman developed jaundice 2 weeks after colonoscopy and propofol anesthesia with bilirubin 4.8 mg/dL, ALT 1313 U/L, Alk P 322 U/L and recovery within 2 weeks; patient also had anti-HCV. Case 1).
Roberts RJ, Barletta JF, Fong J, Schumaker G, Kuper P, Papadopoulos S, Yogaratnam D, et al. (2009). Incidence of propofol-related infusion syndrome in critically ill adults: a prospective, multicenter study. Crit Care. (Prospective study of 1017 critically ill patients on propofol for more than 24 hours; 1.1% developed propofol infusion syndrome but most cases were mild, mortality rate 18% [n=2], and no patient had classical cardiac manifestations).
Jorens PG, Van den Eynden GG. (2009). Propofol infusion syndrome with arrhythmia, myocardial fat accumulation and cardiac failure. Am J Cardiol. (12 year old boy developed rhabdomyolysis [CPK 863,000 U/L] and fatal arrythmias after 5 days of propofol sedation for head trauma; autopsy showed fat in myocardial and skeletal muscles; no mention of the liver).
Sammartino M, Garra R, Sbaraglia F, Papacci P. (2010). Propofol overdose in a preterm baby: may propofol infusion syndrome arise in two hours?. Paediatr Anaesth. (Neonate and preterm baby receiving 2 hours of propofol anesthesia [later found to be an overdose] developed hypotension and bradycardia [ALT 5760 U/L, Alk P 630 U/L, pH 7.35], with rapid recovery and normal enzymes within 1 day).
Wong JM. (2010). Propofol infusion syndrome. Am J Ther. (Review of the history of description of propofol infusion syndrome, diagnosis, prognosis, treatment and suspected mechanisms).
Kneiseler G, Bachmann HS, Bechmann LP, Dechene A, Heyer T, Baba H, Saner F, et al. (2010). A rare case of propofol-induced acute liver failure and literature review. Case Rep Gastroenterol. (35 year old woman developed jaundice and signs of hepatic failure one week after surgery and propofol anesthesia [bilirubin ~18.5 mg/dL, ALT ~1050 U/L, INR ~1.6], liver biopsy showing massive necrosis and mild fat, resolving rapidly over next month).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 2 attributed to anesthetic agents, one to halothane and one to isoflurane, but none to propofol).
Correia LM, Bonilha DQ, Gomes GF, Brito JR, Nakao FS, Lenz L, Rohr MR, et al. (2011). Sedation during upper GI endoscopy in cirrhotic outpatients: a randomized, controlled trial comparing propofol and fentanyl with midazolam and fentanyl. Gastrointest Endosc. (Among 210 patients with cirrhosis undergoing endoscopy comparing propofol and midazolam anesthesia, propofol was more efficacious and had a shorter recovery time than midazolam, side effects were similar; no mention of worsening of liver disease).
Fagà E, De Cento M, Giordanino C, Barletti C, Bruno M, Carucci P, De Angelis C, et al. (2012). Safety of propofol in cirrhotic patients undergoing colonoscopy and endoscopic retrograde cholangiography: results of a prospective controlled study. Eur J Gastroenterol Hepatol. (Among 214 patients undergoing endoscopic procedures under propofol anesthesia, the dose of propofol, duration of sedation and rate of complications was the same in those with cirrhosis [61] as those without [153]).
Wang D, Chen C, Chen J, Xu Y, Wang L, Zhu Z, Deng D, et al. (2013). The use of propofol as a sedative agent in gastrointestinal endoscopy: a meta-analysis. PLoS One. (A systematic review of 22 randomized controlled trials of propofol vs other agents as anesthesia during endoscopy found propofol to provide better sedation and shorter recovery compared to conventional agents, without differences in rates of in adverse events).
Asai A, Yagi M, Tsuchimoto Y, Fukunishi S, Takeshita A, Tsuda Y, Fukuda A, et al. (2013). A rare case of propofol-induced liver injury during modified electroconvulsive therapy in an elderly woman. Intern Med. (A 75 year old woman developed evidence of liver injury 5 days after a third course of electroshock therapy for depression under propofol anesthesia [bilirubin 1.6 mg/dL, ALT 3246 U/L, Alk P 632 U/L, LDH 2841 U/L], resolving within 2 weeks).
Savard M, Dupré N, Turgeon AF, Desbiens R, Langevin S, Brunet D. (2013). Propofol-related infusion syndrome heralding a mitochondrial disease: case report. Neurology. (27 year old woman with intractable status epilepticus developed metabolic acidosis and EKG abnormalities 3 days after starting intravenous propofol therapy which improved on stopping, but she was resistant to all anticonvulsant therapy and subsequent testing found mutations in the POLG1 gene).
Bowdle A, Richebe P, Lee L, Rostomily R, Gabikian P. (2014). Hypertriglyceridemia, lipemia, and elevated liver enzymes associated with prolonged propofol anesthesia for craniotomy. Ther Drug Monit. (39 year old woman with brain tumor undergoing two-stage neurosurgical removal developed lipemic serum during 19 hour infusion of propofol [pH 7.46, triglycerides 15.8 nmol/L] and had elevated ALT postoperatively [ALT 420 U/L, Alk P 130 U/L, bilirubin not given], with improved rapidly thereafter).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to propofol).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 5 cases [0.4%] were attributed to general anesthetics [2 to isoflurane, 2 to sevoflurane, 1 to ketamine] but none to propofol).
Dabir S, Mohammad-Taheri Z, Parsa T, Abbasi-Nazari M, Radpay B, Radmand G. (2015). Effects of propofol versus isoflurane on liver function after open thoracotomy. Asian Cardiovasc Thorac Ann. (Among 88 patients undergoing elective thoracotomy under either sevoflurane or propofol anesthesia, minor transient elevations in ALT and AST occurred at postoperative days 1 and 3 in small numbers of patients, but more frequently with sevoflurane and without symptoms or jaundice).
Mirrakhimov AE, Voore P, Halytskyy O, Khan M, Ali AM. (2015). Propofol infusion syndrome in adults: a clinical update. Crit Care Res Pract. (Review of the history, pathogenesis, risk factors, clinical features and management of propofol infusion syndrome in adults).
Yatabe T, Yamashita K, Yokoyama M. (2015). Drug fever caused by propofol in the intensive care unit. J Anesth. (57 year old woman developed fever after a segmental hepatic resection without evidence of infection while on continuous propofol which continued for 5 days until propofol was stopped [ALT rising to 1316 U/L and AST to 3395 U/L on postoperative day 3]).
Starczewska MH, Mon W, Shirley P. (2017). Anaesthesia in patients with liver disease. Curr Opin Anaesthesiol. (Review and recommendations on anesthesia in patients with liver disease recommends use of propofol or the newer inhalation agents that have minimal hepatic metabolism [sevoflurane and desflurane]).
Vollmer JP, Haen S, Wolburg H, Lehmann R, Steiner J, Reddersen S, Fend F, et al. (2018). Propofol related infusion syndrome: ultrastructural evidence for a mitochondrial disorder. Crit Care Med. (19 year old male with an intracerebral bleed from an arterio-venous malformation underwent surgery with anesthesia and subsequent sedation with propofol for 5 days developing brain edema and tachyarrhythmia followed by asystole, autopsy showing massive hepatic steatosis and electron dense material associated with mitochondria in heart muscle).
Watanabe K, Hikichi T, Takagi T, Suzuki R, Nakamura J, Sugimoto M, Kikuchi H, et al. (2018). Propofol is a more effective and safer sedative agent than midazolam in endoscopic injection sclerotherapy for esophageal varices in patients with liver cirrhosis: a randomized controlled trial. Fukushima J Med Sci. (Among 23 patients undergoing sclerotherapy for esophageal varices sedated with either propofol or midazolam, neurologic worsening occurred to a similar extent with both, but propofol provided better sedation and patient satisfaction).
Ichikawa T, Okuyama K, Kamata K, Masui K, Ozaki M. (2020). Suspected propofol infusion syndrome during normal targeted propofol concentration. J Anesth. (55 year old woman with an orbital mass undergoing awake craniotomy with propofol anesthesia developed lactic acidosis during therapy with appropriately calculated dose, but was found to have plasma levels 12 times higher than predicted and acidosis reversed rapidly with switching anesthetic agents).

## OTHER REFERENCE LINKS

1 Recent References on Propofol: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Propofol/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Propofol: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Propofol)